# Tiagabine

## OVERVIEW

### Introduction

Tiagabine is a unique anticonvulsant used largely as an adjunctive agent in therapy of partial seizures in adults or children. Therapy with tiagabine is not associated with serum aminotransferase elevations, and clinically apparent liver injury from tiagabine has not been reported and must be rare if it occurs at all.

### Background

Tiagabine (tye ag' a been) is a selective gamma aminobutyric acid (GABA) reuptake inhibitor that increases synactive concentrations of this major neuroinhibitory transmitter, thus decreasing spread of abnormal neuronal impulses that contribute to seizures. Tiagabine has been shown to be effective both as monotherapy and in combination with other anticonvulsants for partial seizures. Tiagabine was approved for use in epilepsy in the United States in 1997 and is currently used predominantly as adjunctive therapy with other major anticonvulsants for partial seizures. Tiagabine is occasionally used off-label to treat anxiety disorders and neuropathic pain. Tiagabine is available in tablets of 2, 4, 12 and 16 mg in generic formulations and under the brand name of Gabitril. The recommended initial dose in adults is 4 mg once daily, increasing by 4 to 8 mg at weekly intervals based upon clinical response, but not exceeding 56 mg daily. The dose should be increased and tapered gradually. The most common side effects of tiagabine are dose related and include dizziness, somnolence, impaired concentration, nervousness, nausea, weakness and tremor.

### Hepatotoxicity

Limited data are available on the hepatotoxicity of tiagabine. In clinical trials, therapy with tiagabine was not associated with an increased frequency of serum aminotransferase elevations or liver toxicity. No individual case reports of liver injury from tiagabine have been published and its use has not been associated with hypersensitivity syndromes or autoimmunity. However, its overall use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The apparent absence of significant hepatotoxicity from tiagabine is despite the fact that it is metabolized by the liver and interacts with the CYP 450 system.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tiagabine – Generic, Gabitril®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tiagabine | 115103-54-3 | C20-H25-N-O2-S2 | Tiagabine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 19 February 2018

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; tiagabine is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; tiagabine is not discussed).
McNamara JO. Pharmacology of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 583-607. (Textbook of pharmacology and therapeutics).
Wallace SJ. A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf 1996; 15: 378-93. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine but none reported in children on tiagabine or gabapentin). 8968693
Wilby J, Kainth A, Hawkins N, et al. Clinical effectiveness, tolerability and cost-effectiveness of newer drugs for epilepsy in adults: a systematic review and economic evaluation. Health Technol Assess 2005; 9: 1-157, iii-iv. (Extensive systematic review of anticonvulsant medications including assessment of serious, rare and long-term adverse events; tiagabine adverse events were limited to neurological effects; no mention of hepatotoxicity). 15842952
Pollack MH, Tiller J, Xie F, Trivedi MH. Tiagabine in adult patients with generalized anxiety disorder: results from 3 randomized, double-blind, placebo-controlled, parallel-group studies. J Clin Psychopharmacol 2008; 28: 308-16. (Summary of 3 randomized controlled trials of tiagabine vs placebo for 10 weeks; little or no evidence of efficacy for generalized anxiety disorder found; side effects included headache, dizziness, nausea, fatigue and somnolence but no mention of liver toxicity or ALT elevations). 18480688
Forbes RA, Kalra H, Hackett LP, Daly FF. Deliberate self-poisoning with tiagabine: an unusual toxidrome. Emerg Med Australas 2007; 19: 556-8. (Overdose of tiagabine associated with vomiting, coma, myoclonus, hypertension and pilerection, but no mention of liver injury or jaundice). 18021110
Winhusen T, Somoza E, Ciraulo DA, et al. A double-blind, placebo-controlled trial of tiagabine for the treatment of cocaine dependence. Drug Alcohol Depend 2007; 91: 141-8. (Randomized controlled trial [n=141] of tiagabine vs placebo for cocaine dependence found no evidence of efficacy, but also “no pattern of physical or laboratory abnormality” attributable to tiagabine). 17629631
LaRoche SM. A new look at the second-generation antiepileptic drugs: a decade of experience. Neurologist 2007; 13: 133-9. (Review of second generation anticonvulsants approved since 1994 including felbamate, gabapentin, lamotrigine, topiramate, tiagabine, levetiracetam, oxcarbazepine, zonisamide and pregabalin: no mention of liver toxicity from tiagabine). 17495757
Bauer J, Cooper-Mahkorn D. Tiagabine: efficacy and safety in partial seizures—current status. Neuropsychiatr Dis Treat 2008; 4: 731-6. (Review of pharmacology, clinical efficacy and side effects of tiagabine; no mention of liver toxicity or ALT elevations). 19043517
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, valproate accounted for 6 cases, lamotrigine 5, phenytoin 5, gabapentin and topiramate 1 each; none were due to tiagabine). 18955056
Knowles SR, Dewhurst N, Shear NH. Anticonvulsant hypersensitivity syndrome: an update. Expert Opin Drug Saf 2012; 11: 767-78. (Updated review of anticonvulsant hypersensitivity syndrome; associated with phenytoin, phenobarbital, lamotrigine and carbamazepine and rarely with zonisamide, valproate and oxcarbazepine; tiagabine is not mentioned). 22794330
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants; tiagabine is approved only for treatment of partial seizures and has prominent gastrointestinal and CNS side effects; no mention of hepatotoxicity). 23348233
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none specifically to tiagabine). 25754159
Zaccara G, Giovannelli F, Giorgi FS, Franco V, Gasparini S, Benedetto U. Tolerability of new antiepileptic drugs: a network meta-analysis. Eur J Clin Pharmacol 2017; 73: 811-7. (Metaanalysis of the comparative tolerability of 18 new anticonvulsant agents, found best tolerability [lowest rates of withdrawal for adverse events] with levetiracetam, brivaracetam and gabapentin and lowest scores for tolerability from eslicarbazepine, oxcarbazepine, lacosamide and topiramate; tiagabine had an intermediate level of tolerability). 28378057
Drugs for epilepsy. Med Lett Drugs Ther 2017; 59 (1526): 121-30. (Concise review of the drugs available for therapy of epilepsy does not list tiagabine as either a first or second line drug for epilepsy and mentions that it is approved for adjunctive treatment of partial seizures, but has gastrointestinal and neurologic side effects and is associated with de novo seizures in patients treated off label for bipolar illness or neuropathic pain). 28746301

## OTHER REFERENCE LINKS

1. Recent References on Tiagabine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(tiagabine+AND+Nipecotic+Acids/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tiagabine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=tiagabine)